# Mepolizumab

## OVERVIEW

### Introduction

Mepolizumab is a humanized monoclonal antibody to interleukin-5 (IL-5) which leads to a decrease in production and maturation of eosinophils and results in a reduction in allergic symptoms of asthma and hypereosinophilic syndromes. Mepolizumab has not been associated with serum enzyme elevations during therapy or to instances of clinically apparent drug induced liver injury.

### Background

Mepolizumab (me" poe liz' ue mab) is a recombinant, fully humanized monoclonal antibody to IL-5 which binds to the circulating cytokine and blocks its ability to cause maturation and proliferation of eosinophils. IL-5 is a cytokine growth and stimulating factor which has a selective role in recruiting eosinophils from the bone marrow and promoting their differentiation, activation and survival. Mepolizumab lowers eosinophil counts in patients with hypereosinophilia and also in normal, healthy controls. Therapy with mepolizumab has been shown to reduce the requirement for inhaled corticosteroids and lower the frequency of exacerbations of eosinophilic asthma and other conditions associated with severe hypereosinophilia. Mepolizumab was approved for use in the United States in 2015 for therapy of patients with severe eosinophilic asthma resistant to standard therapy with inhaled corticosteroids. Mepolizumab is available as a sterile powder for reconstitution in single use vials of 100 mg under the brand name Nucala. The recommended dose is 100 mg subcutaneously every 4 weeks. Side effects are not common, but can include injection site reactions, headache, back pain, fatigue, nausea and nasopharyngitis. Rarely, mepolizumab can cause hypersensitivity reactions, but these are usually not severe.

### Hepatotoxicity

In large clinical trials, mepolizumab was not associated with changes in serum aminotransferase levels during therapy, and rates of most adverse reactions were similar in patients who received placebo injections or standard care. There have been no published reports of clinically apparent acute liver injury attributed to mepolizumab therapy. Thus, liver injury from mepolizumab must be very rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Mepolizumab is a humanized monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are often metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Mepolizumab lowers serum eosinophil counts, which seems to have no adverse effects on the liver and does not result in significant immunosuppression.

Drug Class: Antiasthmatic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mepolizumab – Nucala®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mepolizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mepolizumab | 196078-29-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2016

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; mepolizumab is not specifically mentioned).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1031-65. (Textbook of pharmacology and therapeutics).
Rothenberg ME, Klion AD, Roufosse FE, Kahn JE, Weller PF, Simon HU, Schwartz LB, et al.; Mepolizumab HES Study Group. Treatment of patients with the hypereosinophilic syndrome with mepolizumab. N Engl J Med 2008; 358: 1215-28. (Among 84 patients with hypereosinophilic syndromes treated with mepolizumab or placebo intravenously every 4 weeks for 32 weeks, reduction in daily corticosteroid dose was more frequent with treatment and side effects were similar; while there were “no clinically relevant trends” in laboratory tests, one mepolizumab treated subject developed “hepatitis” but no details given). 18344568
Haldar P, Brightling CE, Hargadon B, Gupta S, Monteiro W, Sousa A, Marshall RP, et al. Mepolizumab and exacerbations of refractory eosinophilic asthma. N Engl J Med 2009; 360: 973-84. (Among 61 patients with refractory eosinophilic asthma treated with iv mepolizumab or placebo every 4 weeks for one year, severe exacerbations of asthma were less with mepolizumab [2.0 vs 3.4 per subject] and side effects besides hospitalization for asthma were uncommon; no mention of ALT elevations or hepatotoxicity).
Straumann A, Conus S, Grzonka P, Kita H, Kephart G, Bussmann C, Beglinger C, et al. Anti-interleukin-5 antibody treatment (mepolizumab) in active eosinophilic oesophagitis: a randomised, placebo-controlled, double-blind trial. Gut 2010; 59: 21-30. (Among 11 adults with eosinophilic esophagitis who were treated with iv mepolizumab or placebo twice at one week intervals, eosinophils decreased in esophageal biopsies on mepolizumab, and there were no serious adverse events). 19828470
Pavord ID, Korn S, Howarth P, Bleecker ER, Buhl R, Keene ON, Ortega H, et al. Mepolizumab for severe eosinophilic asthma (DREAM): a multicentre, double-blind, placebo-controlled trial. Lancet 2012; 380 (9842): 651-9. (Among 621 patients with severe eosinophilic asthma treated with iv mepolizumab [75, 250 or 750 mg] or placebo every 4 weeks for 1 year, exacerbations of asthma were less with mepolizumab [1.2 vs 2.4 per year] and adverse events were similar; no mention of ALT elevations or hepatotoxicity). 22901886
Roufosse FE, Kahn JE, Gleich GJ, Schwartz LB, Singh AD, Rosenwasser LJ, Denburg JA, et al. Long-term safety of mepolizumab for the treatment of hypereosinophilic syndromes. J Allergy Clin Immunol 2013; 131: 461-7. (Among 78 patients with hypereosinophilic syndromes treated with mepolizumab for up to 6 years, median prednisone dose fell to zero and there were no hepatic related adverse events or mention of ALT elevations). 23040887
Drugs for asthma and COPD. Treat Guidel Med Lett 2013; 11 (132): 75-86. (Concise summary of guidelines for therapy of asthma mentions that omalizumab [monoclonal antibody to IgE] is approved for use in severe, persistent asthma; no mention of ALT elevations or hepatotoxicity). 23896773
Bel EH, Wenzel SE, Thompson PJ, Prazma CM, Keene ON, Yancey SW, Ortega HG, et al.; SIRIUS Investigators. Oral glucocorticoid-sparing effect of mepolizumab in eosinophilic asthma. N Engl J Med 2014; 371: 1189-97. (Among 135 patients with severe asthma treated with iv mepolizumab or placebo every 4 weeks for 20 weeks, the average daily corticosteroid dose was less and exacerbations of asthma fewer among mepolizumab treated subjects and side effect rates were similar; no mention of ALT elevations or hepatotoxicity). 25199060
Haldar P, Brightling CE, Singapuri A, Hargadon B, Gupta S, Monteiro W, Bradding P, et al. Outcomes after cessation of mepolizumab therapy in severe eosinophilic asthma: a 12-month follow-up analysis. J Allergy Clin Immunol 2014; 133: 921-3. (Among 27 patients with eosinophilic asthma who were withdrawn from mepolizumab therapy after one year, exacerbations of asthma were similar to rates of non-treated subjects). 24418480
Ortega HG, Liu MC, Pavord ID, Brusselle GG, FitzGerald JM, Chetta A, Humbert M, et al.; MENSA Investigators. Mepolizumab treatment in patients with severe eosinophilic asthma. N Engl J Med 2014; 371: 1198-207. (Among 576 patients with severe eosinophilic asthma treated with mepolizumab [75 mg iv or 100 mg sc] or placebo every 4 weeks for 32 weeks, rates of exacerbation were less with mepolizumab [0.83 to 0.93 yearly] vs placebo [1.7 yearly] and side effects were similar; no mention of ALT elevations or hepatotoxicity). 25199059
Mepolizumab (Nucala) for severe eosinophilic asthma. Med Lett Drugs Ther 2016; 58 (1486): 11-2. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of mepolizumab shortly after its approval in the US for eosinophilic asthma, mentions side effects of headache, back pain, fatigue and infusion site reactions, but does not mention ALT elevations or hepatotoxicity). 26761344

## OTHER REFERENCE LINKS

1. Recent References on Mepolizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mepolizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Mepolizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mepolizumab)